# Sulindac

## OVERVIEW

### Introduction

Sulindac is a commonly used nonsteroidal antiinflammatory drug (NSAID) that is available by prescription only and used predominantly to treat chronic arthritis. Sulindac is a rare, but well established cause of idiosyncratic, clinically apparent drug induced liver disease.

### Background

Sulindac (sul' in dak) is a member of the indene acetic acid class of NSAIDs and is chemically related to indomethacin. Like other NSAIDs, sulindac acts through inhibition of tissue cyclooxygenases (Cox-1 and Cox-2) which leads to a decrease in synthesis of proinflammatory prostaglandins, potent mediators of pain and inflammation. Sulindac has analgesic as well as antipyretic and antiinflammatory activities. Sulindac was approved for use in chronic arthritis in the United States in 1978 and its indications have been expanded since. Current indications include acute and chronic use for osteoarthritis, rheumatoid arthritis, ankylosing spondylitis, acute gouty arthritis and for acute bursitis. When given chronically, sulindac has also been shown to decrease adenoma formation in persons with familial adenomatous polyposis. Generic formulations as capsules and tablets are available (150 and 200 mg) and specific commercial names include Clinoril (100, 150, 200 mg). An estimated 250,000 prescriptions for sulindac are written yearly in the United States, a rate that has decreased by at least 70% over the last two decades. The recommended dose in adults is 150 to 200 mg twice daily. As with other NSAIDs, sulindac is generally well tolerated, but side effects can include headache, dizziness, somnolence, gastrointestinal upset, nausea, abdominal discomfort, diarrhea, peripheral edema, infertility, fetal toxicity, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as sulindac include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Chronic therapy with sulindac is associated with a low rate of serum aminotransferase elevations, which are rarely severe and usually self-limited. Clinically apparent acute liver injury from sulindac is well known, but rare; estimated to occur in approximately 1:8000 new users. Sulindac hepatotoxicity typically presents with fever, rash, nausea and vomiting and abdominal pain arising within a few days or weeks of starting the medication and followed shortly thereafter by jaundice. Occasionally, the onset may be delayed, particularly if therapy is intermittent. The clinical pattern suggests an allergic hepatitis and is somewhat similar to the hepatotoxicity of the sulfonamides. The pattern of serum enzyme elevations is usually hepatocellular or mixed at the onset, but may then become cholestatic. However, recovery is usually rapid once sulindac is stopped. Histology is consistent with an allergic hepatitis with spotty necrosis and marked inflammatory cell infiltration with prominence of eosinophils. In many instances, the features of hypersensitivity (such as facial swelling, desquamating rash, pharyngitis, stomatitis, lymphadenopathy, and hypotension) overshadow the liver injury and are more commonly the cause of death. Sulindac can also cause acute liver injury with a more delayed latency with few or no features of hypersensitivity. These cases are usually cholestatic and can be prolonged and lead to vanishing bile duct syndrome.

Likelihood score: A (well established, although rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of sulindac hepatotoxicity appears to be hypersensitivity, since features of immunoallergic hepatitis are common, occurring in at least half of patients. Cases not accompanied by hallmarks of hypersensitivity tend to appear after longer periods of exposure and suggest a possible metabolic, rather than immunologic idiosyncrasy.

### Outcome and Management

The minor aminotransferase elevations that occur in a small proportion of patients during chronic therapy with sulindac are usually subclinical and not progressive. The clinically apparent liver injury from sulindac ranges in severity from mild, self-limited immunoallergic hepatitis, to a prolonged and severe cholestasis to acute liver failure and death. Prognosis may relate, at least in part, to whether sulindac is discontinued promptly and to whether other organs are involved in a hypersensitivity reaction. If hypersensitivity features are prominent or liver injury is severe, corticosteroid therapy may be appropriate, although such intervention has not been proven to be beneficial. Complete recovery with normalization of laboratory abnormalities usually occurs within 1 to 2 months, but can take up to half a year after stopping sulindac. In cases of cholestatic liver injury arising later during sulindac therapy, recovery is often more delayed and instances of vanishing bile duct syndrome have been reported. After immunoallergic liver injury, reexposure to sulindac usually results in rapid recurrence of liver injury and allergic features which can be severe. Thus, rechallenge with sulindac should be avoided. There is rarely cross reactivity in liver injury between sulindac and NSAIDs of other classes, but there may be cross reactivity to allergic reactions to indomethacin and the sulfonamides.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORT

### Case 1. Severe immunoallergic hepatitis attributed to sulindac.(1)

A 51 year old woman with a chronic myeloproliferative disorder developed nausea, fatigue and fever within 24 hours of starting sulindac for back pain. She had no history of liver disease, had no risk factors for viral hepatitis, did not drink alcohol, and was taking no other medications. Physical examination revealed mild jaundice and fever; there was no mention of rash. Initial laboratory tests showed bilirubin of 3.7 mg/dL and 10-fold elevations of ALT with minimal increases in alkaline phosphatase (Table). Tests for hepatitis B and autoantibodies were negative. Ultrasound showed hepatosplenomegaly without biliary tract abnormalities. She recovered rapidly and was well during follow up until she inadvertently restarted sulindac and redeveloped symptoms of fatigue, fever and jaundice within 24 hours. On readmission, she was markedly jaundiced and serum ALT levels were 100-fold elevated. A liver biopsy taken 2 to 3 weeks later showed evidence of hepatocellular necrosis, cholestasis and drug induced liver disease. She recovered rapidly and laboratory tests were near normal within 8 weeks.

#### Key Points

Medication: | Sulindac (150 mg orally taken twice daily for one day)
Pattern: | Hepatocellular (R=9 initially; >100 on rechallenge, later falling to cholestatic range, with R=2.6 and <1.0)
Severity: | 4+ (hospitalized, jaundiced, prolongation of prothrombin time)
Latency: | 1 day to symptoms, 3 days to jaundice
Recovery: | 4 to 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | Two doses of sulindac (200 mg) taken
1 day | 0 | 317 | 275 | 3.7
4 days | 3 days | 307 | 687 | 2.7
9 days | 8 days | 180 | 562 | 1.4
19 days | 18 days | 23 | 14 | 1.3
Time After Restarting | Time After Restopping | 5 months later, two doses of sulindac taken
5 days | 4 days | 4060
8 days | 7 days | 835 | 276 | 21.0 | Protime=18.3 sec
11 days | 10 days | 395 | | 18.0
16 days | 15 days | 71 | 407 | 11.0
19 days | 18 days | 39 | 508 | 6.0
4 weeks | 4 weeks | 30 | 499 | 3.0 | Liver biopsy
10 weeks | 10 weeks | 29 | 290 | 1.2
Normal Values | | <35 | <275 | <1.2

#### Comment

This patient developed an acute immunoallergic hepatitis that was attributed to sulindac, and the inadvertent rechallenge made the association definite. Upon initial presentation, the pattern of enzyme elevations was hepatocellular, but the pattern rapidly became cholestatic over the course of the illness and a liver biopsy was described as showing a cholestatic hepatitis. The patient reported allergy to house dust and pollen, but there was no history of previous drug-allergy. In patients with hypersensitivity reactions to sulindac, it is best to avoid other indene acetic acid NSAIDs such as indomethacin and possibly appropriate to avoid use of sulfonamides. The case history is a strong reminder that patients with drug induced liver disease should be told to discard any remaining pills of the implicated medication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sulindac – Generic, Clinoril®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=SULINDAC&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sulindac | 38194-50-2 | C20-H17-F-O3-S

## CITED REFERENCE

1 Daniele B, Pignata S, D’Agostino L, Vecchione R, Mazzacca G. Sulindac-induced severe hepatitis. Am J Gastroenterol 1988; 83: 1429-31.3195554

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2025

Abbreviations: NSAIDs, nonsteroidal antiinflammatory drugs; Cox-1 and Cox-2, cyclooxygenase-1 and -2.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; sulindac has been implicated in 25 published cases of liver injury with jaundice and 91 reported to the FDA, typically with cholestatic or mixed enzyme elevations and a 5% fatality rate, but usually due to generalized hypersensitivity reactions).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of hepatotoxicity of NSAIDs mentions that sulindac is one of the most commonly implicated NSAIDs in causing liver injury, typically within 1-8 weeks of starting the drug and with a cholestatic pattern of injury with features of hypersensitivity).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Anderson RJ. Severe reaction associated with sulindac administration. N Engl J Med 1979; 300: 735-6. (18 year old woman developed nausea, facial edema, rash and fever 7 days after starting sulindac [bilirubin 9.8 mg/dL, ALT and Alk P "off the scale"], with coagulopathy and thrombocytopenia, resolving on corticosteroid therapy and within 3 weeks of stopping sulindac). 763309
Wolfe PB. Sulindac and jaundice. Ann Intern Med 1979; 91: 656. (46 year old woman developed jaundice 2 weeks after restarting sulindac [bilirubin 10.2 mg/dL, AST 259 U/L, Alk P >350 U/L, GGTP 1897 U/L], resolving within 2 months of stopping). 484983
Smith FE, Lindberg PJ. Life-threatening hypersensitivity to sulindac. JAMA 1980; 244: 269-70. (18 year old woman with rheumatoid arthritis developed high fever and sore throat 5 days after starting sulindac [bilirubin not given; AST 350 U/L, Alk P 227 U/L], resolving in 10 days; recurrence of fever and hypotension 4 hours after rechallenge with a single dose). 7382094
Dhand AK, LaBrecque DR, Metzger J. Sulindac (Clinoril) hepatitis. Gastroenterology 1981; 80: 585-6. (29 year old woman with systemic lupus erythematosus developed fever, rash, arthralgias and nausea 18 days after starting sulindac [bilirubin 2.2 mg/dL, ALT >350 U/L, Alk P 227 U/L], with rapid recovery on stopping; rapid recurrence of high fever, rash and abnormal laboratory tests on reexposure). 7450449
Kaul A, Reddy JC, Fagman E, Smith GF. Hepatitis associated with use of sulindac in a child. J Pediatr 1981; 99: 650-1. (12 year old girl developed fever, nausea, abdominal pain and jaundice 6 weeks after starting sulindac, with rapid recovery, but immediate and severe recurrence [bilirubin 6.5 mg/dL, ALT 67 U/L, Alk P 930 U/L, GGT 815 U/L] within 24 hours of single tablet rechallenge). 7277113
McIndoe GA, Menzies KW, Reddy J. Sulindac (Clinoril) and cholestatic jaundice. N Z Med J 1981; 94: 430-1. (54 year old woman developed jaundice 5 days after completion of a 7 day course of sulindac [bilirubin 5.0 mg/dL, ALT 79 U/L, Alk P 223 U/L]; biopsy showed intrahepatic cholestasis; rapid resolution). 6950284
Giroux Y, Moreau M, Kass TG. Cholestatic jaundice caused by sulindac. Can J Surg 1982; 25: 334-5. (66 year old woman developed jaundice 3 months after starting sulindac [bilirubin 6.9 rising to 20 mg/dL, ALT 328 U/L, Alk P 3 times ULN], resolving in 4 months and recurrence of jaundice within 3 days of rechallenge). 7083082
Kammerer J, Sabardeil S, Rumeau JL, Salson A, El Hage A. [Hepatitis due to Sulindac; a case with review of 3 precedents] Gastroenterol Clin Biol 1982; 6: 712-3. French. (79 year old woman developed fever, arthralgias, rash and jaundice 2 weeks after restarting sulindac which had been used intermittently for 6 months [bilirubin 10.4 mg/dL, ALT 650 U/L, Alk P 5 times ULN]; cholestatic hepatitis on biopsy and rapid resolution upon stopping). 7129022
Park GD, Spector R, Headstream T, Goldberg M. Serious adverse reactions associated with sulindac. Arch Intern Med 1982; 142: 1292-4. (Case series of 4 patients with severe hypersensitivity reactions arising within 5 to 30 days of starting sulindac with variety of organ involvement: skin and liver most common, but also lung, central nervous system, lymph nodes, and bone marrow). 6212034
Whittaker SJ, Amar JN, Wanless IR, Heathcote J. Sulindac hepatotoxicity. Gut 1982; 23: 875-7. (Two women, ages 70 and 71 years, developed jaundice 5 and 30 days after starting sulindac [bilirubin 3.2 and 12.5 mg/dL, AST 211 and 65 U/L, Alk P 325 and 278 U/L], both recovering rapidly upon stopping). 7117907
Fagan EA, Walford N, Hodgson HJ. Sulindac hepatotoxicity. Gut 1983; 24: 1199. (Letter in response to Whittaker [1982] describing a 45 year old woman who developed jaundice 3 months after starting sulindac [bilirubin 11.6 mg/dL, AST 246 U/L, Alk P 595 U/L], resolving within 12 weeks of stopping). 6642281
Klein SM, Khan MA. Hepatitis, toxic epidermal necrolysis and pancreatitis in association with sulindac therapy. J Rheumatol 1983; 10: 512-3. (52 year old woman developed fever, rash and fatigue 14 days after starting sulindac with oral ulcers and facial edema [Stevens-Johnson syndrome] [bilirubin 7.0 mg/dL, AST 590 U/L, Alk P not given], with multiorgan failure and death in 5 days. A second case of 57 year old woman who developed pancreatitis [normal liver tests] 3 months after starting sulindac, recurring rapidly on reexposure). 6224935
Bunde B, Deckers Y, Dequeker J. Fentiazac in rheumatoid arthritis: comparison with sulindac and long-term tolerance. Curr Med Res Opin 1983; 8: 310-4. (Long term therapy with fentiazac in 33 patients; 3 developed hepatotoxicity after 4 months with bilirubin normal to 7.5 mg/dL, ALT 86 to 1040 U/L, Alk P 152 to 290, with rapid resolution after stopping). 6340972
Lewis JH. Hepatic toxicity of nonsteroidal anti-inflammatory drugs. Clin Pharm 1984; 3: 128-38. (Review of hepatotoxicity of NSAIDs; sulindac reported to cause cholestatic or mixed pattern of injury with hypersensitivity features). 6373099
Bodin F, Habibi B, Legendre C, Schaeffer-Plumet J, Riallin P, Darnis F. [Hepatotoxicity of sulindac. A new case] Gastroenterol Clin Biol 1985; 9: 546-7. French. (79 year old woman developed nausea, jaundice and urticaria 4 days after starting sulindac [bilirubin 12 mg/dL, ALT 25 times ULN, Alk P 1.5 times ULN, anti-sulindac antibodies], with eosinophilia and thrombocytopenia, resolving rapidly). 4018492
Gallanosa AG, Spyker DA. Sulindac hepatotoxicity: a case report and review. J Toxicol Clin Toxicol 1985; 23: 205-38. Erratum in: J Toxicol Clin Toxicol 1985-86; 23: 617. (44 year old woman developed abdominal pain with mild ALT [293 U/L] and Alk P [136 U/L] elevations after 6 months of intermittent sulindac therapy, resolving with stopping, but while taking multiple other drugs). 3903180
Wood LJ, Mundo F, Searle J, Powell LW. Sulindac hepatotoxicity: effects of acute and chronic exposure. Aust N Z J Med 1985; 15: 397-401. (3 cases: 57 year old woman developed rash, sore throat, malaise and fever 6 days after starting sulindac [bilirubin 1.0 mg/dL, AST 97 U/L, Alk P 450 U/L], resolving within 7 weeks of stopping; 67 year old man developed rash and pruritus 4 weeks after starting sulindac [bilirubin 1.9 mg/dL, AST 41 U/L, Alk P 450 U/L], persisting while drug was continued and resolving within 1 month of stopping; 42 year old woman developed fatigue and rash 3 weeks after starting sulindac [bilirubin 1.0 mg/dL, AST 230 U/L, Alk P 208 U/L], resolving within 2 months of stopping). 3866535
[Sulindac—a review of adverse effects. Liver reactions are the most characteristics] Lakartidningen 1987; 84: 142, 144. Swedish. (Among adverse events reports to a Swedish registry due to sulindac made between 1982-1986 were 44 cases of liver injury, presenting 2 to 12 weeks after starting sulindac and typically with a mixed pattern of serum enzyme elevations).
Lerche A, Vyberg M, Kirkegaard E. Acute cholangitis and pancreatitis associated with sulindac (clinoril). Histopathology 1987; 11: 647-53. (68 year old man with recurrent attacks of nausea, abdominal pain and fever who was taking sulindac intermittently; selective challenge let to rapid appearance of fever, pain, and nausea [amylase 1542 U/L, ALT 80 U/L, Alk P 400 U/L without jaundice], liver biopsy showing non-specific changes). 3623432
Daniele B, Pignata S, D'Agostino L, Vecchione R, Mazzacca G. Sulindac-induced severe hepatitis. Am J Gastroenterol 1988; 83: 1429-31. (51 year old woman developed nausea, malaise and fever after 2 doses of sulindac with subsequent jaundice [bilirubin 3.6 mg/dL, ALT 317 U/L, Alk P 275 U/L], rapid recovery; inadvertent readministration led to recurrence within 2 days [bilirubin rising to 21 mg/dL, ALT 4060 U/L and Alk P 276 U/L], resolving within 2 months: Case 1). 3195554
Hannequin JR, Doffoel M, Schmutz G. [Hepatitis secondary to current non-steroidal anti-inflammatory agents] Rev Rhum Mal Osteoartic 1988; 55: 983-8. French. (Review of the literature on hepatotoxicity of NSAIDs; 21 cases were attributed to sulindac, occurring at all ages, with latency to onset of 4 days to 2 months, commonly with jaundice and fever and often with rash, one fatality, several instances of recurrence with reexposure suggesting an immunoallergic basis). 3070713
Kromann-Andersen H, Pedersen A. Reported adverse reactions to and consumption of nonsteroidal anti-inflammatory drugs in Denmark over a 17-year period. Dan Med Bull 1988; 35: 187-92. (Summary of 2721 adverse event reports on NSAIDs from 1969-85; hepatic injury in 3% of reports [3 fatal]; rates of hepatic adverse drug reactions per million daily doses was highest for sulindac [1.2] compared to diclofenac [0.4], tolmetin [0.3] phenylbutazone [0.2], ibuprofen, naproxen, ketoprofen or indomethacin [0.1]). 2966038
Tarazi EM, Harter JG, Zimmerman HJ, Ishak KG, Eaton RA. Sulindac-associated hepatic injury: analysis of 91 cases reported to the Food and Drug Administration. Gastroenterology 1993; 104: 569-74. (Analysis of reports of sulindac hepatotoxicity submitted to FDA between 1978 and 1986: among 91 cases, 50% presented within 4 weeks, 65% were women, 67% had jaundice, 50% cholestatic enzymes, 55% fever, 48% rash, 40% pruritus, 35% eosinophilia, and 5% died, mostly from hypersensitivity reaction). 8425699
Giardiello FM, Hamilton SR, Krush AJ, Piantadosi S, Hylind LM, Celano P, et al. Treatment of colonic and rectal adenomas with sulindac in familial adenomatous polyposis. N Engl J Med. 1993; 328: 1313-6. (Small trial showing decrease in adenoma formation in high risk subjects on sulindac therapy; no patient had serious side effects or liver enzyme elevations). 8385741
García Rodríguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. (Retrospective cohort study of cases of acute liver injury in England after exposure to NSAIDs; 23 cases [none fatal] including 5 from ibuprofen, 4 diclofenac, 4 naproxen, 2 mefenamic acid, 3 ketoprofen, 2 piroxicam, 2 fenbufen and 3 sulindac; highest incidence rate [risk] for sulindac). 8297198
Manoukian AV, Carson JL. Nonsteroidal anti-inflammatory drug-induced hepatic disorders. Incidence and prevention. Drug Saf 1996; 15: 64-71. (Review of pharmacoepidemiology of NSAID hepatotoxicity, highlighting sulindac as having the strongest evidence of causing liver injury: 148 per 100,000 users with odds ratios for liver injury of 4.1 to 5.0). 8862964
Davies NM, Watson MS. Clinical pharmacokinetics of sulindac. A dynamic old drug. Clin Pharmacokinet 1997; 32: 437-59. (Sulindac is rapidly absorbed and metabolized to sulphide which is pharmacologically active and then to a sulphone, which is inactive and excreted in the urine). 9195115
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Extensive review of large population based studies of NSAID liver injury, found that hepatotoxicity is rare; sulindac had highest estimated rates of 31 to 221/100,000 person-years and relative risk estimates of 2.9 to 4.1). 9041931
Bjorkman D. Nonsteroidal anti-inflammatory drug-associated toxicity of the liver, lower gastrointestinal tract, and esophagus. Am J Med 1998; 105: 17S-21S. (Review of gastrointestinal side effects of NSAIDs, stresses that intestinal side effects are far more common than liver). 9855171
Tolman KG. Hepatotoxicity of non-narcotic analgesics. Am J Med 1998; 105(1B): 13S-19S. (Review of hepatotoxicity of analgesics including NSAIDs). 9715830
Guldenschuh I, Hurlimann R, Muller A, Ammann R, Mullhaupt B, Dobbie Z, et al. Relationship between APC genotype, polyp distribution, and oral sulindac treatment in the colon and rectum of patients with familial adenomatous polyposis. Dis Colon Rectum 2001; 44: 1090-7. (Open label study of sulindac found regional decreases in adenoma occurrence in 17 patients with familial adenomatous polyposis; no patient had side effects or serum enzyme elevations). 11535846
O’Connor N, Dargan PI, Jones AL. Hepatocellular damage from non-steroidal anti-inflammatory drugs. QJM 2003; 96: 787-91. (Review of hepatotoxicity of NSAIDs stressing the increased risk from sulindac and diclofenac). 14566034
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure: several were attributed to diclofenac, but none to sulindac). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; 21 drugs were associated with >50 cases, including diclofenac [15th], but not sulindac). 16054882
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther 2006; 28: 1123-32. (Among more than 300,000 spontaneous reports of adverse events due to NSAIDs, 3% being hepatic; the proportion of adverse events that were hepatic was highest for bromfenac [20.7%] and nimesulide [14.4%], but the proportion was also elevated for sulindac [9.9%] and diclofenac [4.7%]). 16982289
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Data from Spanish and French pharmacovigilance systems from 1982-2001 found higher risk of hepatic to other types of adverse events for sulindac; 59 cases due to sulindac were listed, mostly from France). 16867024
Aithal GP, Day CP. Nonsteroidal anti-inflammatory drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 563-75, vi-vii. (Review of hepatotoxicity of NSAIDs; sulindac has been the NSAID most consistently associated with hepatotoxicity; features of hypersensitivity were present in two-thirds of cases). 17723920
Björnsson E, Kalaitzakis E, Olsson R. The impact of eosinophilia and hepatic necrosis on prognosis in patients with drug-induced liver injury. Aliment Pharmacol Ther 2007; 25: 1411-21. (Analysis of case reports of drug induced liver injury for frequency and significance of eosinophilia; among 23 published cases of sulindac hepatotoxicity, the average age was 51 years, 86% were women, only 10% were hepatocellular, 12% had eosinophilia peripherally, 40% had eosinophils in liver histology, and mortality rate was 4% [1 case]). 17539980
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; sulindac was not listed). 18955056
Thierman S, Dhaliwal G, Sooriash L, Baudendistel T. Flushing out the diagnosis. J Hosp Med 2009; 4: 569-73. (42 year old woman with history of asthma developed fever, rash and jaundice 6 weeks after starting sulindac for ankle pain [bilirubin 4.6 mg/dL, ALT 667 U/L, Alk P 146 U/L, eosinophils 15%], with rapid improvement on stopping and recurrence of fever and rash on restarting twice). 20013860
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 7 of which were due to NSAIDs: 4 were linked to bromfenac, 2 diclofenac, 1 etodolac, but none to sulindac). 20949552
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; sulindac is associated with a 5- to 10-fold greater risk of hepatotoxicity compared to other NSAIDs). 21128314
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 44, including diclofenac [the most commonly used NSAID] in 7; sulindac not specifically mentioned). 23325533
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for sulindac or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDs [n=62, 32%], and specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac [n=16], but also celecoxib [3], meloxicam [3], etodolac [2], ibuprofen [2], oxaprozin [2], valdecoxib [1] and sulindac [1], but not naproxen). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; naproxen and other NSAIDs not mentioned). 28782674
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin). 29469052
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187.. (In a review of 3312 published cases of drug-induced liver injury using RUCAM to define causality, diclofenac ranked 5^th^ and ibuprofen ranked 8^th^ in frequency, whereas sulindac is not mentioned). 30354694
Gulmez SE, Unal US, Lassalle R, Chartier A, Grolleau A, Moore N. Risk of hospital admission for liver injury in users of NSAIDs and nonoverdose paracetamol: Preliminary results from the EPIHAM study. Pharmacoepidemiol Drug Saf. 2018;27:1174-1181.. (In a case-population controlled study of a French hospitalization claims database, 63 cases of acute liver injury were identified, 13 of which had been exposed recently to an NSAID including 6 to diclofenac, 4 to ibuprofen, 3 to ketoprofen, but none to sulindac). 30112779
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Ma J, Björnsson ES, Chalasani N. The safe use of analgesics in patients with cirrhosis: a narrative review. Am J Med. 2024;137:99-106.. (Review of the safety of analgesic use in patients with cirrhosis, mentions that acetaminophen is considered the safest nonopioid but that the dose should be limited to 2 g daily with prolonged therapy in persons with cirrhosis and that NSAIDs are generally thought to be contraindicated in patients with cirrhosis, but celecoxib can be used at typical doses with Child’s class A cirrhosis (compensated), but should be reduced by 50% in patients with Child’s B and avoided in those with Child’s C cirrhosis). 37918778
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-Update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, but only 1 to naproxen and sulindac). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] due to diclofenac, 14 [3.0%] to nimeslide, and 11 [2.4%] to ibuprofen; the implicated agents of the remaining 5 NSAID cases were not mentioned). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Sulindac: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(sulindac/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sulindac: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sulindac)